# Tiotropium

## OVERVIEW

### Introduction

Tiotropium is a synthetic anticholinergic agent that is used as an inhalant for treatment of acute bronchospasm due to chronic bronchitis or emphysema. Tiotropium has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Tiotropium (tye" oh troe' pee um) is a synthetic quaternary ammonium anticholinergic which inhibits the muscarinic actions of acetylcholine on autonomic nerve endings, decreasing bronchial smooth muscle contractions and alleviating bronchospasm in patients with chronic obstructive pulmonary disease (COPD). Tiotropium has potent activity against muscarinic acetylcholine receptors found in bronchial smooth muscle. Its quaternary ammonium structure decreases its ability to cross lipid membranes such as the blood brain barrier. Tiotropium was approved for use in the United States in 2004 for use as a respiratory inhalant as maintenance treatment of bronchospasm associated with chronic bronchitis and emphysema. Tiotropium is available under the brand name Spiriva in capsules of 18 mcg for use in an inhaler (not to be swallowed). The typical dose in adults is two inhalations of the powder from one capsule once daily. When given by inhaler, tiotropium has minimal systemic absorption. Side effects of tiotropium are mild, but can include the typical anticholinergic effects of dryness of the mouth and eyes, visual blurring, constipation, tachycardia and palpitations, anxiety and restlessness. Tiotropium use can cause paradoxical bronchospasm. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Like other anticholinergic agents, tiotropium has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to its low systemic absorption when administered by inhaler.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on the Anticholinergic Agents.

Drug Class: Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tiotropium – Spiriva®, Tiova®

DRUG CLASS

Anticholinergic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tiotropium)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Tiotropium | 136310-93-5 | C19-H22-N-O4-S2.Br | Tiotropium Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Tiotropium: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Tiotropium/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Tiotropium: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tiotropium)